# Voclosporin

## OVERVIEW

### Introduction

Voclosporin is an orally available calcineurin inhibitor and potent immunosuppressive agent which is used in combination with mycophenolate mofetil and corticosteroids to treat acute lupus nephritis. Voclosporin may be associated with low rate of transient serum enzyme elevations during treatment but has not been linked to instances of clinically apparent acute liver injury with jaundice.

### Background

Voclosporin (voe” kloe spor’ in) is a potent immunosuppressive agent that is used as therapy for patients with systemic lupus erythematosus and acute lupus nephritis. Voclosporin is a derivative of cyclosporin A, a cyclic polypeptide of 11 amino acids, initially isolated from a fungus species (Beauveria nivea). Cyclosporine and voclosporin have potent immunosuppressive activity, acting as calcineurin inhibitors which block T cell activation decreasing cytokine secretion and immunologically mediated cell injury. Voclosporin differs from cyclosporine by a single amino acid, but appears to have a higher degree of selectivity and somewhat more potency. Voclosporin has been developed as an immunomodulatory agent for therapy of autoimmune conditions rather than as an antirejection agent for organ transplantation. In several clinical trials, voclosporin in combination with mycophenolate mofetil and low doses of corticosteroids was shown to alleviate the renal injury in acute lupus nephritis, decreasing proteinuria and preventing major worsening of estimated glomerular filtration rate (eGFR). Voclosporin was approved for use in adults with acute lupus nephritis in the United States in 2021. It is available in capsules of 7.9 mg under the brand name Lupkynis. The typical dose is 27.7 mg (3 capsules) twice daily used in combination with mycophenolate mofetil (2 grams daily) and high dose corticosteroids followed by a rapid taper to maintenance dosing. Therapy requires careful monitoring for renal function and should be administered only by physicians with expertise in management of lupus nephritis and complications of calcineurin inhibitor therapy. Common side effects include nausea, diarrhea, abdominal discomfort, dizziness and paresthesias. Voclosporin can also cause worsening of renal function and hypertension, and dose adjustments are often required (in up to 50% of cases). Less common but potentially severe adverse events include increased risk of severe infections and malignancies, drug-drug interactions, prolongation of the QT interval, hyperkalemia and neurotoxicity.

### Hepatotoxicity

In large randomized controlled trials of voclosporin, serum aminotransferase levels were transiently elevated in 3% of patients, but rates were similar in controls receiving conventional therapy (2%). Similar to cyclosporine, voclosporin therapy is associated with minor increases in alkaline phosphatase and bilirubin levels, although values usually remain within the normal range. In the prelicensure studies of voclosporin, there were no instances of clinically apparent liver injury attributable to therapy. Clinical experience with this agent, however, has been limited and other calcineurin inhibitors have been found to cause rare instances of hepatic injury, which are generally cholestatic, mild-to-moderate in severity and self-limited in course once treatment is stopped.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which voclosporin might cause liver injury is unknown. Other calcineurin inhibitors such as cyclosporine and tacrolimus are associated with serum enzyme elevations and rare instances of cholestatic liver injury. Voclosporin is metabolized in the liver, largely by CYP 3A4 and is susceptible to drug-drug interactions, particularly with strong inducers (such as rifampin and St. John's wort) or strong inhibitors of CYP 3A4 (such as ketoconazole) which should be avoided.

### Outcome and Management

Serum enzyme elevations during therapy with voclosporin are generally mild and without accompanying symptoms or jaundice. Appearance of liver injury during therapy should lead to a search for other possible causes. But if none are found, dosing should be interrupted if values rise above 5 times the upper limit of normal (ULN), with caution in restarting if they subsequently fall into the normal range.

Drug Class: Immunosuppressive Agents

Other Drugs in the Subclass, Calcineurin Inhibitors: Cyclosporine, Tacrolimus

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Voclosporin – Lupkynis®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Voclosporin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Voclosporin | 515814-01-4 | C63-H111-N11-O12
Cyclosporine | 59865-13-3 | C62-H111-N11-O12

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2021

Abbreviations used: eGFR, estimated glomerular filtration rate.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999; voclosporin is not mentioned but cyclosporine is discussed; cyclosporine therapy is associated with a high rate of cholestatic liver enzyme elevations ranging from 4-86% and has been linked to occasional instances of cholestatic hepatitis, some features of which are reproducible in animal models).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/213716Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA integrated review of the voclosporin application for safety and efficacy which mentions [pages 202-3] that mean values of ALT, Alk P, GGT and bilirubin remained in the normal range although mean levels of Alk P and bilirubin increased slightly during therapy; the rate of ALT or AST elevations above 3 times ULN was similar in incidence to that in placebo recipients [3% vs 2%] and were transient and asymptomatic, except for one case of liver injury with jaundice in a patient with pulmonary tuberculosis who was receiving antimycobacterial therapy).
Bissonnette R, Papp K, Poulin Y, Lauzon G, Aspeslet L, Huizinga R, Mayo P, et al., ISA247 Psoriasis Study Group. (2006). A randomized, multicenter, double-blind, placebo-controlled phase 2 trial of ISA247 in patients with chronic plaque psoriasis. J Am Acad Dermatol. (Among 201 adults with plaque psoriasis treated with voclosporin [0.5 mg/kg or 1.5 mg/kg] or placebo daily for 12 weeks, improvements in psoriasis occurred in 15% and 45% of voclosporin vs 0% of placebo recipients, and adverse events more frequent with voclosporin included nausea, diarrhea, abdominal pain, vomiting, dizziness, and paresthesias, while there were “no significant changes” in hepatic laboratory features).
Busque S, Cantarovich M, Mulgaonkar S, Gaston R, Gaber AO, Mayo PR, Ling S, et al. (2011). PROMISE Investigators. The PROMISE study: a phase 2b multicenter study of voclosporin (ISA247) versus tacrolimus in de novo kidney transplantation. Am J Transplant. (Among 334 patients undergoing renal transplantation treated with either voclosporin [3 doses] or tacrolimus for 24 weeks, rates of biopsy proven acute cellular rejection were comparable in the 4 groups as were adverse event rates).
Rovin BH, Solomons N, Pendergraft WF, Dooley MA, Tumlin J, Romero-Diaz J, Lysenko L, et al., AURA-LV Study Group. (2019). A randomized, controlled double-blind study comparing the efficacy and safety of dose-ranging voclosporin with placebo in achieving remission in patients with active lupus nephritis. Kidney Int. (Among 265 patients with active lupus nephritis treated with voclosporin [23.7 mg or 39.5 mg] vs placebo twice daily for 48 weeks, complete renal responses occurred in 49% and 40% vs 24%, while serious adverse events were more frequent with voclosporin [28% and 25% vs 16%] as were infections [12% and 14% vs 8%] and all-cause mortality [11% and 2.3% vs 1%]).
Heo YA. (2021). Voclosporin: first approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy and safety of voclosporin shortly after its approval for use in lupus nephritis mentions common adverse events as being transient decline in GFR, hypertension, headache, anemia and cough).
Rovin BH, Teng YKO, Ginzler EM, Arriens C, Caster DJ, Romero-Diaz J, Gibson K, et al. (2021). Efficacy and safety of voclosporin versus placebo for lupus nephritis (AURORA 1): a double-blind, randomised, multicentre, placebo-controlled, phase 3 trial. Lancet. (Among 457 patients with active lupus nephritis treated with voclosporin [23.7 mg] or placebo twice daily for 52 weeks, “complete renal response” rates were higher with voclosporin [41% vs 23%], while serious adverse events were similar [21% vs 21%] and deaths were fewer in number [1 vs 5]).
(2021). Voclosporin (Lupkynis) for lupus nephritis. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of voclosporin, a calcineurin inhibitor approved for lupus nephritis mentions that therapy can increase the risk of bacterial, viral and fungal infections, can prolong the QT interval, and can cause hyperkalemia and neurotoxicity; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Voclosporin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Voclosporin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Voclosporin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Voclosporin)